# Incretin-Based Drugs

## OVERVIEW

The incretins are gastrointestinal polypeptide hormones that act to modulate insulin secretion from pancreatic beta cells. These hormones include glucagon-like peptide-1 (GLP-1) and gastric inhibitory peptide (GIP), and they are secreted from the upper gastrointestinal tract in response to feeding. They act on the pancreas, causing insulin release even before blood glucose levels are elevated. Both hormones are polypeptides that are rapidly cleared from the serum by the enzyme dipeptidyl peptidase-4 (DPP-4). The incretin pathway provides several potential targets for therapy of type 2 diabetes, the main ones being DPP-4 inhibitors and GLP-1 analogues. These incretin-based hypoglycemic agents are relatively new and they have not been implicated as common causes of drug induced liver injury. These two groups of incretin-based drugs are quite different in chemical structure, pharmacology and safety profile and are discussed separately.

Drug Class: Antidiabetic Agents

Drugs in the Subclass, Incretin-Based Drugs:

- Dipeptidyl Peptidase-4 (DPP-4) Inhibitors
  - Alogliptin
  - Linagliptin
  - Saxagliptin
  - Sitagliptin
- Glucagon-Like Peptide-1 (GLP-1) Analogues
  - Albiglutide
  - Dulaglutide
  - Exenatide
  - Liraglutide
  - Lixisenatide
  - Semaglutide

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Alogliptin | 850649-62-6 | C18-H21-N5-O2.C7-H6-O2 | Alogliptin chemical structure
Linagliptin | 668270-12-0 | C25-H28-N8-O2 | Linagliptin Chemical Structure
Saxagliptin | 945667-22-1 | C18-H25-N3-O2.H2O | Saxagliptin Chemical Structure
Sitagliptin | 486460-32-6 | C16-H15-F6-N5-O | Sitagliptin Chemical Structure